# Enzalutamide

## OVERVIEW

### Introduction

Enzalutamide is a third generation, oral nonsteroidal antiandrogen used in the treatment of metastatic castration-resistant prostate cancer. Enzalutamide is associated with a low rate of serum enzyme elevation during therapy but has not been linked to cases of clinically apparent liver injury with jaundice.

### Background

Enzalutamide (en" za loo' ta mide) is an androgen receptor antagonist which binds to the intracellular receptor and prevents its translocation to the nucleus and subsequent DNA binding thereby blocking its activity. Therapy with enzalutamide has been shown to prolong relapse free as well as overall survival in men with metastatic, castration-resistant prostate cancer who had previously failed other forms of treatment. Enzalutamide was approved for use in the United States in 2012. Current indications are for castration-resistant prostate cancer and for metastatic, high risk castration-sensitive prostate cancer. In patients without previous bilateral orchiectomy, enzalutamide should be used in combination with a gonadotropin releasing hormone (GnRH) analog to insure optimal androgen suppression. Enzalutamide is available as capsules of 40 mg and tablets of 40 mg and 80 mg under the brand name Xtandi. The recommended dose is 160 mg by mouth once daily. Common side effects include fatigue, diarrhea, anorexia, weight loss, constipation, joint and muscle pain, hot flushes, headaches, dizziness, hypertension, hypokalemia, fluid retention, and edema. Rare, but potentially serious side effects include seizures and posterior reversible encephalopathy.

### Hepatotoxicity

In preregistration controlled trials, serum aminotransferase elevations occurred in up to 10% patients treated with enzalutamide, but similar somewhat high rates occurred in patients receiving placebo (~9%). The liver test abnormalities were generally mild, transient and not associated with symptoms or jaundice. ALT elevations above 5 times the ULN were rare (0.2%) and also no more frequent than with placebo therapy. In addition, clinically apparent liver injury with jaundice was not reported in the preregistration trials of enzalutamide, and clinically apparent liver injury and hepatitis are not mentioned in the product label. Since the approval and more wide scale use of enzalutamide, there have been no publications or descriptions of the clinical features of hepatotoxicity with jaundice associated with its use. Thus, clinically apparent liver injury due to enzalutamide must be rare, if it occurs at all.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of the liver enzyme elevations that occur during enzalutamide therapy is unknown. Enzalutamide is extensively metabolized in the liver predominantly by CYP 3A4 and 2D6 and is a strong inducer of CYP 3A4 and a moderate inducer of 2D6. Enzalutamide is susceptible to drug-drug interactions with inhibitors, inducers or substrates of these microsomal enzymes.

### Outcome and Management

The liver injury linked to enzalutamide therapy has been generally mild, consisting of transient and asymptomatic elevations in serum aminotransferase levels. Enzalutamide has not been linked to cases of acute liver failure, chronic hepatitis or vanishing bile duct syndrome. There is no information on cross sensitivity to hepatic injury between enzalutamide and other antiandrogens, such as flutamide, bicalutamide, or abiraterone.

Drug Class: Antineoplastic Agents, Antiandrogens

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Enzalutamide – Xtandi®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Enzalutamide)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Enzalutamide | 915087-33-1 | C21-H16-F4-N4-O2

## ANNOTATED BIBLIOGRAPHY

References updated: 15 March 2023

Abbreviations: LHRH, luteinizing hormone releasing hormone; PSA, prostate-specific antigen.

Zimmerman HJ. Hepatotoxic effects of oncotherapeutic and immunosuppressive agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 673-708. (Expert review of hepatotoxicity of cancer chemotherapeutic agents published in 1999 before the availability of enzalutamide).
DeLeve LD. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam, Elsevier, 2013, p. 541-68. (Review of hepatotoxicity of cancer chemotherapeutic agents; enzalutamide is not discussed).
Moy B, Lee RJ, Smith M. Hormone therapy in prostate cancer. Natural products in cancer chemotherapy: hormones and related agents. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1763-9. (Textbook of pharmacology and therapeutics discusses the androgen receptor antagonists flutamide, bicalutamide and nilutamide, but not enzalutamide).
Tran C, Ouk S, Clegg NJ, Chen Y, Watson PA, Arora V, Wongvipat J, et al. (2009). Development of a second-generation antiandrogen for treatment of advanced prostate cancer. Science. (Description of development of unique antiandrogen molecules that block the translocation of the androgen receptor to the nucleus and the transcriptional activity of the receptor).
Scher HI, Fizazi K, Saad F, Taplin ME, Sternberg CN, Miller K, de Wit R, et al. (2012). AFFIRM Investigators. Increased survival with enzalutamide in prostate cancer after chemotherapy. N Engl J Med. (Among 1199 adult men with castration-resistant prostate cancer treated with enzalutamide [160 mg daily] or placebo, mean survival was improved from 13.6 to 17.3 months and side effects included abnormal ALT, AST or bilirubin in 1% on enzalutamide vs 2% on placebo).
(2013). Enzalutamide (Xtandi) for prostate cancer. Med Lett Drugs Ther. (Concise summary of the mechanism of action, clinical efficacy, safety and costs of enzalutamide shortly after its approval in the US; does not mention ALT elevations or hepatotoxicity).
Tombal B, Borre M, Rathenborg P, Werbrouck P, Van Poppel H, Heidenreich A, Iversen P, et al. (2014). Enzalutamide monotherapy in hormone-naive prostate cancer: primary analysis of an open-label, single-arm, phase 2 study. Lancet Oncol. (Among 67 men with hormone treatment naive prostate cancer treated with enzalutamide [160 mg daily] for 25 weeks, prostate specific antigen levels decreased by more than 80% in 62 patients [93%], and side effects included gynecomastia, fatigue, hot flush, diarrhea, and nausea, while “no hepatic adverse events were reported for any patient”).
Bennett LL, Ingason A. (2014). Enzalutamide (Xtandi) for patients with metastatic, resistant prostate cancer. Ann Pharmacother. (Review of the pharmacology, clinical efficacy and safety of enzalutamide, mentions that it is "generally well tolerated" and does not mention ALT elevations or hepatotoxicity).
Beer TM, Armstrong AJ, Rathkopf DE, Loriot Y, Sternberg CN, Higano CS, Iversen P, et al. (2014). PREVAIL Investigators. Enzalutamide in metastatic prostate cancer before chemotherapy. N Engl J Med. (Among 1717 men with metastatic prostate cancer treated with enzalutamide or placebo, overall and progression-free survival were improved with enzalutamide and its side effects included fatigue, back pain, constipation, arthralgia, hot flushes, diarrhea and poor appetite; ALT elevations occurred in 1% of patients in both groups and were rarely above 5 times ULN).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 49 [5.5%] were attributed to antineoplastic agents of which only 1 was due to an antiandrogen [bicalutamide]).
Joshua AM, Shore ND, Saad F, Chi KN, Olsson CA, Emmenegger U, Scholz M, et al., Enzalutamide Expanded Access Study Investigators. (2015). Safety of enzalutamide in patients with metastatic castration-resistant prostate cancer previously treated with docetaxel: expanded access in North America. Prostate. (Among 507 patients with metastatic, castration-resistant prostate cancer receiving enzalutamide in an open access program until commercial availability [mean duration 2.6 months], there was "no clinical laboratory evidence of drug-related hepatotoxicity").
Tombal B, Borre M, Rathenborg P, Werbrouck P, Van Poppel H, Heidenreich A, Iversen P, et al. (2015). Long-term efficacy and safety of enzalutamide monotherapy in hormone-naïve prostate cancer: 1- and 2-year open-label follow-up results. Eur Urol. (Among 67 patients with hormone naïve prostate cancer treated with enzalutamide for 25 weeks [Tombal 2014], 45 remained on therapy for 2 years with sustained decreases in prostate specific antigen [PSA] levels; no hepatic adverse events were mentioned).
Ning YM, Brave M, Maher VE, Zhang L, Tang S, Sridhara R, Kim G, et al. (2015). U.S. Food and Drug Administration Approval Summary: enzalutamide for the treatment of patients with chemotherapy-naïve metastatic castration-resistant prostate cancer. Oncologist. (Summary of the clinical efficacy and safety analysis of trials of enzalutamide therapy of advanced prostate cancer that led to its approval by the FDA; mentions side effects of fatigue, back pain, diarrhea, hot flush, edema, muscle pain and weakness, headache, diarrhea and insomnia, but does not mention ALT elevations or hepatotoxicity).
Higano CS, Beer TM, Taplin ME, Efstathiou E, Hirmand M, Forer D, Scher HI. (2015). Long-term safety and antitumor activity in the phase 1-2 study of enzalutamide in pre- and post-docetaxel castration-resistant prostate cancer. Eur Urol. (Among 140 patients with castration-resistant prostate cancer continued on enzalutamide therapy for up to 4 years, no new safety concerns arose and there was no mention of ALT elevations or hepatotoxicity).
Shore ND, Chowdhury S, Villers A, Klotz L, Siemens DR, Phung D, van Os S, et al. (2016). Efficacy and safety of enzalutamide versus bicalutamide for patients with metastatic prostate cancer (TERRAIN): a randomised, double-blind, phase 2 study. Lancet Oncol. (Among 375 patients with metastatic prostate cancer treated with enzalutamide [160 mg] vs bicalutamide [50 mg] once daily, median progression free survival was greater with enzalutamide [15.7 vs 5.8 months] and side effect rates were similar, ALT elevations occurring in 2.2% vs 1.1% with only 1 patient in each group having elevations above 5 times ULN; no mention of clinically apparent liver injury).
Beer TM, Armstrong AJ, Rathkopf D, Loriot Y, Sternberg CN, Higano CS, Iversen P, et al. (2017). Enzalutamide in men with chemotherapy-naïve metastatic castration-resistant prostate cancer: extended analysis of the phase 3 PREVAIL Study. Eur Urol. (Extended analysis of the randomized controlled trial of enzalutamide for chemotherapy-naïve metastatic castration-resistant prostate cancer [Beer et al; 2014] found that response rates remained higher in the enzalutamide treated group and the adverse event profile remained the same).
Crawford ED, Schellhammer PF, McLeod DG, Moul JW, Higano CS, Shore N, Denis L, et al. (2018). Androgen receptor targeted treatments of prostate cancer: 35 years of progress with antiandrogens. J Urol. (Review of the development of antiandrogen therapies of prostate cancer starting with discovery of the androgen sensitive nature of prostate cancer, the effects of orchiectomy, followed by the development of androgen receptor antagonists, first generation agents flutamide and nilutamide, second generation agent bicalutamide and third generation agents enzalutamide, apalutamide and darolutamide that have more potent androgen receptor inhibition).
Attard G, Borre M, Gurney H, Loriot Y, Andresen-Daniil C, Kalleda R, Pham T, et al., PLATO collaborators. (2018). Abiraterone alone or in combination with enzalutamide in metastatic castration-resistant prostate cancer with rising prostate-specific antigen during enzalutamide treatment. J Clin Oncol. (Among 251 patients with metastatic prostate cancer who had rising PSA levels despite enzalutamide therapy who were treated with abiraterone with or without enzalutamide, progression free survival was similar with both groups [5.7% vs 5.6%], while ALT elevations were more frequent with combination therapy [10% vs 2%] as was hypertension [6% vs 2%]).
Liu J, Agyapong G, Misra D, Taylor CD, Hirsh DA. (2019). A rare case of idiopathic cholestasis: Clinical conundrums complicating enzalutamide therapy in metastatic prostate cancer. Clin Case Rep. (88 year old man with metastatic prostate cancer developed jaundice one week after stopping a 5 month course of bicalutamide and starting enzalutamide while continuing on leuprolide [bilirubin 3.8 mg/dL, ALT 45 U/L, Alk P 654 U/L, GGT 988 U/L, INR 1.2], with little improvement after stopping all therapy and death from suspected progressive disease 2 weeks later).
Ryoo BY, Palmer DH, Park SR, Rimassa L. (2021). Efficacy and safety results from a phase 2, randomized, double-blind study of enzalutamide versus placebo in advanced hepatocellular carcinoma. Clin Drug Investig. (Among 165 patients with advanced hepatocellular carcinoma treated with enzalutamide [160 mg] or placebo once daily, the median overall survival rates were similar in both groups [7.8 vs 7.1 months] and adverse event rates were higher with enzalutamide [98% vs 89%] including fatigue [35% vs 18%], decreased appetite [32% vs 22%] and nausea [32% vs 22%], while rates of AST elevation above 5 times ULN were similar [11% vs 11%]; no mention of serious hepatic adverse events).
Vaishampayan UN, Heilbrun LK, Monk P, Tejwani S, Sonpavde G, Hwang C, Smith D, et al. (2021). Clinical efficacy of enzalutamide vs bicalutamide combined with androgen deprivation therapy in men with metastatic hormone-sensitive prostate cancer: a randomized clinical trial. JAMA Netw Open. (Among 71 men with advanced prostate cancer treated with either enzalutamide [160 mg] or bicalutamide [50 mg] daily with androgen-depletion therapy using a LHRH analog, the biochemical and overall survival outcomes were greater with enzalutamide than bicalutamide, particularly in Black subjects; no mention of hepatic adverse events).
Halabi S, Jiang S, Terasawa E, Garcia-Horton V, Ayyagari R, Waldeck AR, Shore N. (2021). Indirect comparison of darolutamide versus apalutamide and enzalutamide for nonmetastatic castration-resistant prostate cancer. J Urol. (Comparison of outcome and adverse events in published randomized, placebo controlled trials of darolutamide, apalutamide and enzalutamide for castration-resistant prostate cancer suggested that efficacy as assessed by improvement in metastasis-free survival was similar for all three agents, but that darolutamide therapy was associated with lower rates of adverse events, particularly fatigue, rash, falls, seizures, fractures and cognitive disorders; no mention of ALT elevations or hepatotoxicity).
Fleshner L, Berlin A, Hersey K, Kenk M, Lajkosz K, Nguyen S, Wise J, et al. (2022). Time trends of drug-specific actionable adverse events among patients on androgen receptor antagonists: implications for remote monitoring. Can Urol Assoc J. (Among 828 patients with prostate cancer who received abiraterone or enzalutamide or both, adverse events arose in 29% on abiraterone, 26% on enzalutamide, usually within the first 3 months; abnormal liver tests arose in 48% vs 23% and hypertension in 47% vs 77%, but there were no adverse event related deaths).
Payne H, Robinson A, Rappe B, Hilman S, De Giorgi U, Joniau S, Bordonaro R, et al. (2022). A European, prospective, observational study of enzalutamide in patients with metastatic castration-resistant prostate cancer: PREMISE. Int J Cancer. (Among 1732 men with metastatic castration-resistant prostate cancer in a prospective, open-label study, the mean time to treatment failure was 12.9 months and adverse event rates ranged from 51-62% per year; no mention of liver related adverse events).
Scailteux LM, Despas F, Balusson F, Campillo-Gimenez B, Mathieu R, Vincendeau S, Happe A, et al. (2022). Hospitalization for adverse events under abiraterone or enzalutamide exposure in real-world setting: A French population-based study on prostate cancer patients. Br J Clin Pharmacol. (Among 11,534 patients newly started on abiraterone or enzalutamide therapy for prostate cancer who were enrolled in the French National Health Insurance System Database between 2013 and 2017, liver test abnormalities were more frequent with abiraterone [17% vs 6%] as were acute kidney injury and atrial fibrillation, while “hepatitis” was rare [<0.1%]).

## OTHER REFERENCE LINKS

1 Recent References on Enzalutamide: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Enzalutamide/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Enzalutamide: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Enzalutamide)